# Pertuzumab

## OVERVIEW

### Introduction

Pertuzumab is a humanized monoclonal antibody to the human epidermal growth factor receptor 2 (HER2) which is used in combination with other antineoplastic agents in the therapy of refractory, advanced breast cancer. Pertuzumab has been implicated in rare instances of transient, occasionally marked serum enzyme elevations, but has not been linked to instances of clinically apparent liver injury with jaundice.

### Background

Pertuzumab (per tooz’ ue mab) is humanized monoclonal antibody to HER2 which is a growth factor receptor that is overexpressed in 20% to 25% of breast cancers. The interaction of epidermal growth factor (EGF) with HER2 results in rapid cell growth and proliferation via intracellular pathways that include MAP and PI3 kinase. Blockage of this pathway results in cell cycle arrest and cell death. Pertuzumab binds to the dimerization site on the HER2 receptor and prevents pairing of receptors and blocks their intracellular signaling. Because the binding site for pertuzumab is different from that of trastuzumab (another monoclonal antibody to HER2), they can be used together and are believed to have additive antitumor effects. Pertuzumab in combination with trastuzumab and docetaxel has been shown to increase the rate of pathological complete responses in women with advanced HER2 positive breast cancer and it was approved for this indication in 2012. Indications were subsequently expanded to use as neoadjuvant therapy for early or advanced, metastatic breast cancer. Pertuzumab is available in multiple use vials of 420 mg under the brand name Perjeta. The typical dose is 840 mg intravenously initially, followed by 420 mg every three weeks. Common side effects include diarrhea, nausea, fatigue, rash, abdominal pain and cardiac dysfunction. Rare, but serious side effects include infusion reactions (usually with the initial dose), cardiomyopathy (especially when combined with an anthracycline), pneumonitis and fetal toxicity.

### Hepatotoxicity

In large registration trials of pertuzumab for breast and other cancers, rates of serum enzyme elevations were usually not reported. In the FDA summary review the incidence of hepatic disorders was similar with pertuzumab as with placebo when added to standard breast cancer chemotherapy (9.6% vs 10.1%) as were rates of ALT elevations (3.0% vs 3.7%). Rare instances of ALT elevations above 5 times the ULN have been reported in studies of pertuzumab combined with carboplatin, docetaxel and trastuzumab or with trastuzumab emtansine. A single instance of acute liver failure was reported in a patient who received pertuzumab, trastuzumab and docetaxel in a clinical trial, but few details were given, and the injury was attributed to docetaxel. In all of these situations, the role of pertuzumab as opposed to the other antineoplastic agents being used was uncertain. Since its approval and wider scale use, there have been no reports of clinically apparent, acute liver injury with jaundice attributed to pertuzumab.

Likelihood score: E (unlikely cause of clinically apparent acute liver injury).

### Mechanism of Injury

Pertuzumab is a human monoclonal antibody and is unlikely to have intrinsic hepatotoxicity, but it may interact with endothelial growth factor receptors present on normal cells and cause injury by its direct cellular effects on epithelial growth factor pathways.

### Outcome and Management

The liver injury attributed to pertuzumab has not been well characterized and there is no information on possible cross sensitivity to the injury among different monoclonal antibodies or therapies directed at epidermal growth factor receptors. Pertuzumab is usually used in combination with trastuzumab and other antineoplastic agents which are generally considered more likely causes of liver injury.

Drug Class: Antineoplastic Agents, Monoclonal Antibodies

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Pertuzumab – Perjeta®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/drugInfo.cfm?setid=17f85d17-ab71-4f5b-9fe3-0b8c822f69ff)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Pertuzumab | 380610-27-5 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 15 April 2020

Abbreviations: TNF, tumor necrosis factor; HER-2, human epidermal growth factor receptor 2.

Zimmerman HJ. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity published in 1999, well before the availability of most monoclonal antibody therapies).
Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of immunosuppressive drugs mentions that "the biological immunosuppressants are largely free from hepatotoxicity, with the exception of the tumor necrosis factor [TNF] alpha antagonists").
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
https://www.accessdata.fda.gov/drugsatfda_docs/nda/2012/125409Orig1s000MedR.pdf (FDA website with product label and medical review of pertuzumab concludes that “overall, pertuzumab does not appear to be significantly hepatotoxic”).
Gianni L, Lladó A, Bianchi G, Cortes J, Kellokumpu-Lehtinen PL, Cameron DA, Miles D, et al. (2010). Open-label, phase II, multicenter, randomized study of the efficacy and safety of two dose levels of Pertuzumab, a human epidermal growth factor receptor 2 dimerization inhibitor, in patients with human epidermal growth factor receptor 2-negative metastatic breast cancer. J Clin Oncol. (Among 78 women with metastatic breast cancer [HER2 negative] treated with one of 2 doses of pertuzumab every 3 weeks, response rates were minimal and side effects were common, including diarrhea [51%], nausea [27%], fatigue [24%], rash [21%], abdominal pain [156%] and cardiac dysfunction [11%]; no mention of ALT elevations or hepatotoxicity).
Gianni L, Pienkowski T, Im YH, Roman L, Tseng LM, Liu MC, Lluch A, et al. (2012). Efficacy and safety of neoadjuvant pertuzumab and trastuzumab in women with locally advanced, inflammatory, or early HER2-positive breast cancer (NeoSphere): a randomised multicentre, open-label, phase 2 trial. Lancet Oncol. (Among 417 women with HER2 positive breast cancer treated with 1 of 4 regimens of pertuzumab, docetaxel and trastuzumab, highest rates of response and side effects occurred with triple therapy, including one death from fulminant hepatitis after a 4th cycle; no mention of rates of ALT elevations ).
Baselga J, Cortés J, Kim SB, Im SA, Hegg R, Im YH, Roman L, et al., CLEOPATRA Study Group. (2012). Pertuzumab plus trastuzumab plus docetaxel for metastatic breast cancer. N Engl J Med. (Among 808 women with metastatic breast cancer [HER2 positive] treated with trastuzumab and docetaxel, the addition of pertuzumab increased progression free survival from 12.4 to 18.5 months and increased side effects of diarrhea [46% to 67%] and febrile neutropenia [8% to 14%]; no mention of hepatotoxicity).
(2012). Pertuzumab (Perjecta) for HER2-positive metastatic breast cancer. Med Lett Drugs Ther. (Concise review of mechanism of action, efficacy and safety of pertuzumab as therapy of metastatic breast cancer [HER2 positive] shortly after its approval for this use in the US; no mention of ALT elevations or hepatotoxicity).
(2013). Pertuzumab (Perjeta) for preoperative use in HER2-positive breast cancer. Med Lett Drugs Ther. (Concise review of mechanism of action, efficacy and safety of pertuzumab as neoadjuvant [preoperative] therapy for HER2 positive breast cancer mentions cardiomyopathy, anaphylaxis and embryotoxicity, but not hepatotoxicity or ALT elevations).
Miller KD, Diéras V, Harbeck N, Andre F, Mahtani RL, Gianni L, Albain KS, et al. (2014). Phase IIa trial of trastuzumab emtansine with pertuzumab for patients with human epidermal growth factor receptor 2-positive, locally advanced, or metastatic breast cancer. J Clin Oncol. (Among 64 women with HER2 positive metastatic breast cancer [HER2 positive] treated with the combination of pertuzumab and trastuzumab emtansine [every 3 weeks], common side effects were fatigue [61%], nausea [50%] and diarrhea [39%] and "hepatic dysfunction" in 38% with ALT levels above 5 times ULN in 9%).
Gianni L, Pienkowski T, Im YH, Tseng LM, Liu MC, Lluch A, Starosławska E, et al. (2016). 5-year analysis of neoadjuvant pertuzumab and trastuzumab in patients with locally advanced, inflammatory, or early-stage HER2-positive breast cancer (NeoSphere): a multicentre, open-label, phase 2 randomised trial. Lancet Oncol. (Among 417 women with locally advanced HER2 positive breast cancer treated with neoadjuvant regimens using trastuzumab, pertuzumab and docetaxel in various combinations, adverse event rates were similar [95-100%] and serious adverse events included febrile neutropenia and diarrhea; no mention of ALT elevations or hepatotoxicity).
von Minckwitz G, Procter M, de Azambuja E, Zardavas D, Benyunes M, Viale G, Suter T, et al., APHINITY Steering Committee and Investigators. (2017). Adjuvant pertuzumab and trastuzumab in early HER2-positive breast cancer. N Engl J Med. (Among 4805 women with operable HER2 positive breast cancer given standard adjuvant therapy and trastuzumab with either pertuzumab or placebo, disease recurrence was lower with pertuzumab [7.1% vs 8.7%], while adverse event rates were similar except for diarrhea [71% vs 45%] and rash [26% vs 20%]; no mention of ALT elevations or hepatotoxicity).
Hurvitz SA, Martin M, Symmans WF, Jung KH, Huang CS, Thompson AM, Harbeck N, et al. (2018). Neoadjuvant trastuzumab, pertuzumab, and chemotherapy versus trastuzumab emtansine plus pertuzumab in patients with HER2-positive breast cancer (KRISTINE): a randomised, open-label, multicentre, phase 3 trial. Lancet Oncol. (Among 444 patients with advanced HER2 positive breast cancer given neoadjuvant therapy with trastuzumab emtansine with pertuzumab vs trastuzumab, pertuzumab and docetaxel with carboplatin, response rates were lower with trastuzumab emtansine but so were adverse event rates with ALT elevations in 10% vs 21% that were above 5 times ULN in 2% vs 1% ).
Woodward N, De Boer RH, Redfern A, White M, Young J, Truman M, Beith J. (2019). Results from the first multicenter, open-label, phase IIIb study investigating the combination of pertuzumab with subcutaneous trastuzumab and a taxane in patients with HER2-positive metastatic breast cancer (SAPPHIRE). Clin Breast Cancer. (Among 50 women with metastatic HER2 positive breast cancer treated with the combination of pertuzumab, trastuzumab and taxane, adverse events included diarrhea, fatigue, neuropathy, alopecia, rash and nausea; no mention of ALT elevations or hepatotoxicity).
Swain SM, Miles D, Kim SB, Im YH, Im SA, Semiglazov V, Ciruelos E, et al., CLEOPATRA study group. (2020). Pertuzumab, trastuzumab, and docetaxel for HER2-positive metastatic breast cancer (CLEOPATRA): end-of-study results from a double-blind, randomised, placebo-controlled, phase 3 study. Lancet Oncol. (Long term follow up of randomized controlled trial of trastuzumab with docetaxel with or without pertuzumab for advance HER2 positive breast cancer [Baselga 2012] demonstrated continued superior overall survival in comparison to placebo [median of 57 vs 41 months]; adverse event rates were similar except for diarrhea and rash; no mention of ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Pertuzumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Pertuzumab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Pertuzumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Pertuzumab)